# Lurbinectedin

## OVERVIEW

### Introduction

Lurbinectedin is an antineoplastic alkylating agent and synthetic derivative of trabectedin that is used to treat refractory, metastatic small cell lung cancer. Lurbinectedin therapy is associated with a high rate of transient serum enzyme elevations during treatment and with occasional instances of clinically apparent liver injury with jaundice.

### Background

Lurbinectedin (loor” bin ek’ te din) is a synthetic derivative of the natural product trabectedin that acts as an alkylating agent and is used in cancer chemotherapy. Lurbinectedin binds to the minor groove of DNA, allowing for alkylation of guanine causing double-strand DNA breaks and apoptotic cell death, particularly in the absence of viable DNA repair pathways. Lurbinectedin demonstrated cytotoxic activity against several cancer cell lines in vitro and in murine models of human small cell lung cancer (SCLC). Pilot studies and moderately sized, open label trials of lurbinectedin in patients with refractory, relapsed metastatic SCLC showed promising results with response rates of 35% overall. Lurbinectedin was given accelerated approval in 2020 as therapy of patients with metastatic SCLC after relapse following first line therapy with platinum based antineoplastic agents. Lurbinectedin is given intravenously and is available in 4 mg amounts of lyophilized powder in single use vials under the brand name Zepzelca. The typical dose is 3.2 mg/m^2^ body surface area as a 60 minute infusion every 3 weeks, continued until disease progression or unacceptable toxicity. Premedication with dexamethasone and with serotonin antagonists (such as ondansetron) before each infusion is recommended. Side effects are common and include bone marrow suppression, anemia, neutropenia, thrombocytopenia, fatigue, nausea, vomiting, diarrhea, constipation, anorexia, abdominal pain, musculoskeletal pain, fever, dyspnea, cough, infections, peripheral neuropathy, and headache. Serious adverse events include severe myelosuppression, neutropenic sepsis, hepatotoxicity, and embryo-fetal toxicity.

### Hepatotoxicity

Elevations in serum aminotransferase levels arise in approximately two-thirds of patients treated with lurbinectedin and elevations above 5 times the upper limit of normal occur in 4% to 5% of patients. Pretreatment with dexamethasone appears to decrease the degree and frequency of enzyme elevations. The elevations arise within 2 to 5 days of the intravenous infusion, rise to maximal levels between 5 and 9 days, and generally fall to baseline values within 2 to 3 weeks. Minor elevations in serum alkaline phosphatase and bilirubin are also common. However, clinically apparent liver injury with jaundice from lurbinectedin is uncommon. On the other hand, patients with underlying liver disease appear to be at increased risk for septicemia and multiorgan failure as a result of chemotherapy, and monitoring of liver tests before and during lurbinectedin therapy is recommended. The severe liver injury typically mimics acute decompensation of an underlying cirrhosis with modest elevations in serum enzymes and worsening jaundice and hepatic synthetic dysfunction. Immunoallergic and autoimmune features are uncommon. Fatalities are generally due to sepsis and multiorgan failure rather than typical acute liver failure.

Likelihood score: D (possible cause of clinically apparent liver injury, generally in the setting of preexisting liver disease and use of high doses).

### Mechanism of Injury

The transient serum aminotransferase elevations that occur with lurbinectedin therapy are most likely due to direct hepatotoxicity. Lurbinectedin is extensively metabolized by the hepatic cytochrome P450 system, predominantly CYP3A4, and is susceptible to drug-drug interactions. Agents that inhibit CYP3A activity may cause elevated levels of lurbinectedin and increased toxicity.

### Outcome and Management

The severity of liver injury from lurbinectedin ranges from mild elevations in liver enzymes to marked aminotransferase elevations to clinically apparent liver injury with jaundice and multiorgan (including hepatic) failure. Most severe cases occur in patients with preexisting liver disease. For these reasons, patients should be monitored with routine liver tests before and during therapy, and therapy delayed until resolution of the abnormalities, or stopped if liver test abnormalities persist.

Drug Class: Antineoplastic Agents, Alkylating Agents

Other Drugs in Same Class: Trabectedin

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Lurbinectedin – Zepzelca®

DRUG CLASS

Antineoplastic Agents, Alkylating Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Lurbinectedin)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Lurbinectedin | 497871-47-3 | C41-H44-N4-O10-S

## ANNOTATED BIBLIOGRAPHY

References updated: 22 November 2022

Zimmerman HJ. Oncotherapeutic and immunosuppressive agents. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 673-708. (Expert review of hepatotoxicity of cancer chemotherapeutic agents published in 1999 before the availability of trabectedin or lurbinectedin).
DeLeve LD. Cancer chemotherapy. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 541-68. (Review of hepatotoxicity of cancer chemotherapeutic agents; trabectedin is listed as causing serum enzyme elevations and rare instances of liver failure when given in high doses; lurbinectedin is not discussed).
Wellstein A, Giaccone G, Atkins MB, Sausville EA. Trabectedin. Cytotoxic agents. Chemotherapy of neoplastic diseases. In, Brunton LL, Hilal-Dandan R, Knollman BC, eds. Goodman & Gilman's the pharmacological basis of therapeutics. 13th ed. New York: McGraw-Hill, 2018, pp. 1194. (Textbook of pharmacology and therapeutics).
FDA. https://www.accessdata.fda.gov/drugsatfda_docs/nda/2020/213702Orig1s000MultidisciplineR.pdf (FDA web site with product labels and multidisciplinary clinical reviews of approved drug applications, mentions that 41% of the 554 lurbinectedin treated subjects had serious adverse events, resulting in drug discontinuation in 9% mostly due to myelosuppression; ALT elevations arose in 61% of participants which were above 5 times ULN in 6%, arising within 3-49 days of starting [median=8 days] and lasting 7 days on average; however, there were no cases of clinically apparent hepatotoxicity with jaundice).
van Kesteren Ch, de Vooght MMM, López-Lázaro L, Mathôt RA, Schellens JH, Jimeno JM, Beijnen JH. (2003). Yondelis (trabectedin, ET-743): the development of an anticancer agent of marine origin. Anticancer Drugs. (Review of the development, chemistry, mode of action and preclinical and clinical studies of trabectedin suggests that it acts by binding to the minor groove of DNA, thereby interfering with transcription factor binding to DNA and blocking transcription).
Wahab A, Rafae A, Mushtaq K, Venkata K, Sarmad R. (2021). Lurbinectedin-induced tumor lysis syndrome in small cell neuroendocrine cancer of the cecum: a first-ever case report. Am J Case Rep. (38 year old woman with metastatic, refractory small cell neuroendocrine cancer, was started on lurbinectedin as a third-line therapy and 5 days later developed abdominal pain and acute renal failure with creatinine 4.0 mg/dL, uric acid 19.3 mg/dL, phosphate 7.6 mg/dL, ALT 49 U/L, AST 429 U/L, Alk P 599 U/L, and bilirubin 2.3 mg/dL followed by pancytopenia, septicemia, multiorgan failure and death 4 days after admission).
Markham A. (2020). Lurbinectedin: first approval. Drugs. (Review of the mechanism of action, history of development, clinical efficacy, and safety of lurbinectedin shortly after its accelerated approval in the US; mentions that therapy is associated with high rates of ALT and AST elevations but makes no mention of serious hepatic adverse events or clinically apparent liver injury).
Trigo J, Subbiah V, Besse B, Moreno V, López R, Sala MA, Peters S, et al. (2020). Lurbinectedin as second-line treatment for patients with small-cell lung cancer: a single-arm, open-label, phase 2 basket trial. Lancet Oncol. (Among 105 adults with relapsed SCLC after first-line therapy who were treated with lurbinectedin [3.2 mg/m^2^ every 3 weeks], the overall response rate was 35%, and adverse events arose in most patients, 72% had ALT elevations which were above 5 times ULN in 5%, but there were no treatment related deaths and no clinically apparent drug induced liver injury).
(2022). Lurbinectedin (Zepzelca) for small-cell lung cancer. Med Lett Drugs Ther. (Concise review of the mechanism of action, pharmacology, clinical efficacy, safety and costs of lurbinectedin shortly after its approval for use in the US, mentions that ALT and AST elevations during therapy are common).
Aix SP, Ciuleanu TE, Navarro A, Cousin S, Bonanno L, Smit EF, Chiappori A, et al. Combination lurbinectedin and doxorubicin versus physician's choice of chemotherapy in patients with relapsed small-cell lung cancer (ATLANTIS): a multicentre, randomised, open-label, phase 3 trial. Lancet Respir Med. 2022:S2213-2600(22)00309-5. Epub ahead of print. (Among 613 adults with advanced SCLC with relapse after platinum-based chemotherapy treated with lurbinectedin [2 mg/m^2^] and doxorubicin [40 mg/m^2^] every 21 days or standard chemotherapy, overall median survival was 8.6 vs 7.6 months, overall response rates were 32% vs 30%, and while adverse events arose in 98% of patients, lurbinectedin had a more favorable hematological safety than standard chemotherapy; ALT elevations and hepatotoxicity not mentioned).
Manzo A, Sforza V, Carillio G, Palumbo G, Montanino A, Sandomenico C, Costanzo R, et al. (2022). Lurbinectedin in small cell lung cancer. Front Oncol. (Review of the role of lurbinectedin as a second line therapy of relapsed SCLC, a cancer with a poor prognosis and few options, lurbinectedin being the first second-line therapy approved for this indication in several decades but providing only a modest extension of survival, the major toxicities of lurbinectedin being hematologic although serum aminotransferase elevations are frequent during therapy [72% in phase 2 trials]).
Singh S, Jaigirdar AA, Mulkey F, Cheng J, Hamed SS, Li Y, Liu J. (2021). Zet al. FDA approval summary: lurbinectedin for the treatment of metastatic small cell lung cancer. Clin Cancer Res. (Review of the regulatory history and basis of the FDA accelerated approval of lurbinectedin in 2020 as a second-line therapy of refractory SCLC, mentions that safety was based on 554 patients treated in open label studies mentions that hepatotoxicity was observed with ALT elevations in 61% of treated participants with a median onset of 8 days and median duration of 7 days).

## OTHER REFERENCE LINKS

1 Recent References on Lurbinectedin: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Lurbinectedin/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D:%222999/12/31%22%5BEDat%5D))
2 Trials on Lurbinectedin: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Lurbinectedin)